# Moringa

## OVERVIEW

### Introduction

Moringa oleifera is a tree native to India, the leaves, seeds, bark, roots, sap, and flowers of which are consumed as a food and used in traditional medicine. Moringa is well tolerated and has not been linked to elevations in serum enzymes during therapy, but has recently been implicated in a case of acute anicteric hepatitis.

### Background

Moringa oleifera is a deciduous tree, native to the Indian subcontinent but cultivated worldwide in tropical and subtropical climates. The leaves, seeds, flowers, and roots of moringa are used widely as a source of food as well as in traditional medicine. Also known as the drumstick tree (for its distinctive pods), the horseradish tree (for its aromatic roots), and the Ben nut oil tree (for its seed oils), Moringa oleifera is widely cultivated as a protein- and vitamin-rich food source and for its potential medicinal activities. Studies in cell culture and animal models suggest that extracts of moringa leaf have a multitude of potential beneficial activities, including antioxidant, antidiabetic, antilipidemic, antihypertensive, antiulcer, anticancer, antimicrobial, antiinflammatory, immunomodulatory, and protective activity for the liver, kidney, heart, lung, and testes. Phytochemical analyses of moringa extracts show the presence of polyphenols, phenolic acids, flavonoids, glycolates and alkaloids. The specific components responsible for the purported medicinal activity of moringa have not been definitely shown but candidates mentioned include kaempferol, myricetin, niazirin, flavonoid, and moringin. Extracts of leaves and seeds of moringa have been purported to have activity in improving energy and boosting the immune system as well as being helpful for asthma, growth, obesity, lactation, diabetes, and hyperlipidemia, but none of these activities have been convincingly demonstrated in clinical studies in humans, and moringa is not approved for any medical condition in the United States. Small, short term clinical trials of moringa leaf extracts have suggested that it lowers fasting blood sugar and improves elevated hemoglobulin A1c and serum cholesterol levels. However, the reported effects in these studies were modest and of unclear clinical benefit. Moringa is available as a dietary supplement in multiple forms including capsules, powders, and solutions typically in concentrations ranging from 100 mg to 1 gram, and the recommended daily doses varies accordingly from 500 mg to 5 or 6 grams. In clinical trials, moringa was reported to be well tolerated with no adverse effects and no changes in routine hematologic and chemistry values including liver tests.

### Hepatotoxicity

In small clinical trials, moringa preparations have not been implicated in causing serum enzyme or bilirubin elevations. Furthermore, until recently there have been no published reports of clinically apparent liver injury attributed to moringa extracts. In multiple large registries and case series of drug and dietary supplement induced liver injury, moringa was not listed as an implicated agent until a recent case series from South America reported on a single case attributed to Morinaga oleifera from Brazil. Details of the case were subsequently published and are shown below as Case 1. Moringa is widely used as a food supplement and appears to be well tolerated so that liver injury from its use must be very rare.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

Drug Class: Herbal and Dietary Supplements

Other names: Arango, Narango, Indian horseradish, Ben nut oil.

## CASE REPORT

### Case 1. Acute anicteric hepatitis attributed to Moringa oleifera.(1)

A 60 year old woman with dyslipidemia, gastroesophageal reflux, and hypothyroidism developed fatigue and nausea and was found to have elevations in serum aminotransferase levels one month after starting MAX Moringa Oleifera (4 capsules twice daily) to boost her energy. She had no previous history of liver disease or drug allergies, did not drink alcohol, and had no risk factors for viral hepatitis. Her other medications included levothyroxine for hypothyroidism and ezetimibe for hyperlipidemia. She stopped both the ezetimibe and the Moringa capsules. Blood tests showed ALT 380 U/L, AST 258 U/L, and alkaline phosphatase 128 U/L, all of which had been normal when tested a year before (Table). She was not jaundiced and was not hospitalized. Serum enzymes were near normal two months later and she decided to restart the moringa capsules. Within a month, she redeveloped nausea and fatigue and liver tests had worsened. She denied jaundice, dark urine, itching, rash, and fever. Serum bilirubin was normal (0.6 mg/dL) as was the INR (1.0). Tests for acute hepatitis A, B, C, and E were negative as were serologic tests for EBV and CMV infection. Routine autoantibodies including ANA, SMA and AMA were negative. An abdominal ultrasound was normal without evidence for biliary obstruction or organomegaly. She stopped the moringa and liver tests improved and were normal two months later. The herbal product was labeled as containing Moringa oleifera and vitamin C, but concentrations were not provided.

#### Key Points

Medication: | Moringa oleifera
Pattern: | Hepatocellular (R=5.0 initially; 10.6 with recurrence)
Severity: | Mild (anicteric)
Latency: | 1 month
Recovery: | 2 months
Other medications: | Ezetimibe, levothyroxine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre – 9 months | | 22 | 22 | 72 | | Routine testing in previous year
0 | | Started Moringa oleifera and Ezetimibe
1 month | 0 | 380 | 258 | 128 | | Stopped both drugs, R = 5.0
| 2 months | 85 | 57 | 100 | | Restarted Moringa
1 month | 0 | 1080 | 591 | 186 | 0.6 | Stopped Moringa, R = 10.6
| 1 months | 71 | 54 | 98 | 0.2
6 months | 2 months | 30 | 30 | 77 | 0.2 | Asymptomatic
Upper Limit of Normal | | 69 | 46 | 126 | 1.3

#### Comment

Middle aged woman developed serum enzyme elevations a month after starting the combination of ezetimibe for hyperlipidemia and Moringa oleifera for boosting energy and restoring well being. She thought that the moringa was having a beneficial effect but stopped both drugs after developing fatigue and having abnormal liver tests. Two months later her liver tests had improved, and against the advice of her physicians, she restarted moringa. The liver injury recurred with symptoms and more significant elevations in ALT and AST but still without jaundice. Other causes for acute liver injury were appropriately excluded and the liver test abnormalities and symptoms improved after stopping moringa for a second time. Moringa is a widely used food and herbal product and has not been implicated previously in causing drug induced liver injury. This case, however, was reasonably convincing with a well documented recurrence on restarting moringa without the ezetimibe and careful exclusion of other common causes of acute hepatocellular injury. The product was not available for chemical testing for contaminants and confirmation of the presence of moringa. In further follow up more than a year later, her liver enzyme levels remained normal.

[Additional information on this case was kindly provided by Dr. Vinicius Nunes].

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Moringa oleifera – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Moringin | 73255-40-0 | C14-H17-NO5-S
Myricetin | 529-44-2 | C15-H10-O8

## CITED REFERENCE

1 Secundino C, Nunes V, Gameleira SdSL, Schinoni MI, Parana R. Hepatic injury induced by Moringa oleifera with rechallenge. On J Complement & Alt Med. 2022; 7: OJCAM.2022.07.000665. Not in PubMed.

## ANNOTATED BIBLIOGRAPHY

References updated: 15 July 2024

Abbreviations: DILI, drug-induced liver injury; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal and dietary supplements [HDS] are discussed, but not moringa).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements published in 2007; no mention of moringa).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Among 778 spontaneous reports of adverse reactions to herbal and alterative medicines to a national Swedish Registry, no cases were attributed to moringa). 19650152
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbal products identified 185 publications on 60 different herbs, herbal drugs, and supplements but does not list or mention moringa). 22928722
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies; no mention of moringa). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs and dietary supplements collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to moringa). 25043597
Stohs SJ, Hartman MJ. Review of the safety and efficacy of Moringa oleifera. Phytother Res. 2015;29:796-804. (Summary of the phytochemistry and biologic activities of Moringa oleifera describing results of 5 small clinical studies done in humans demonstrating its safety and beneficial effects on fasting blood glucose, HbA1c, and lipid levels). 25808883
Stohs SJ, Kaats GR, Preuss HG. Safety and efficacy of Banaba-Moringa oleifera-green coffee bean extracts and vitamin D3 in a sustained release weight management supplement. Phytother Res. 2016;30:681-8. (Among 30 adults with type 2 diabetes treated with a proprietary mixture of banaba, moringa, and green coffee bean extracts for 60 days, there were no adverse side effects, no changes in routine blood chemistry results including ALT and AST, and slight increases in fat free mass with similar decreases in fat mass, but no change in body weight or body mineral density suggesting that the product might be beneficial in weight management). 26871553
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss moringa). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish Drug-Induced Liver Injury Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of moringa). 29307848
Gambino-Shirley KJ, Tesfai A, Schwensohn CA, Burnett C, Smith L, Wagner JM, Eikmeier D, et al. Multistate outbreak of Salmonella Virchow infections linked to a powdered meal replacement product-United States, 2015-2016. Clin Infect Dis. 2018;67:890-896. (Epidemiologic investigation of an outbreak of 35 cases of Salmonella Virchow infections in 24 states in the US implicated a contaminated raw food product made from organic powdered moringa leaf extracts imported from South Africa). 29522200
Alam MA, Quamri MA, Haider N. Efficacy and safety of Barg-e-Sahajna (Moringa oleifera Lam.) in primary hypothyroidism. Drug Metab Pers Ther. 2021;37:21-26. (Among 8 adults with hypothyroidism treated with Moringa oleifera leaves [5 grams twice daily] for 45 days, serum TSH levels decreased into the normal range while T4 and T3 increased, while “no adverse effect was testimonied” and serum levels of ALT and AST did not change). 34449175
Grosshagauer S, Pirkwieser P, Kraemer K, Somoza V. The future of moringa foods: a food chemistry perspective. Front Nutr. 2021;8:751076. (A review of the phytochemistry of Moringa oleifera mentions that the high protein and vitamin content of the plant along with ease of cultivation makes it an attractive food source, but the problems of variation in processing and possibility of contamination in heavy metals and mycotoxins make its safety an important reservation). 34796194
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on HDS induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90], Herbalife products [64], kava kava [62], and greater celandine [48]; moringa is not listed or discussed). 34307603
Secundino C, Nunes V, Gameleira SdSL, Schinoni MI, Parana R. Hepatic injury induced by Moringa oleifera with rechallenge. On J Complement & Alt Med. 2022; 7: OJCAM.2022.07.000665. Not in PubMed. (60 year old woman with hyperlipidemia developed elevated liver tests one month after starting moringa oleifera and ezetimibe [ALT 380 U/L, Alk P 128 U/L, bilirubin not done] that improved upon stopping and then recurred one month after restarting [ALT 1080 U/L, Alk P 186 U/L, bilirubin 0.6, INR 1.0], which again improved on stopping: Case 1].
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American Drug-Induced Liver Injury Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3]; one case was attributed to moringa oleifera). 33434654
Dzuvor CKO, Pan S, Amanze C, Amuzu P, Asakiya C, Kubi F. Bioactive components from Moringa oleifera seeds: production, functionalities and applications- a critical review. Crit Rev Biotechnol. 2022;42:271-293. (Review of the biologic activities of moringa extracts focusing upon ingredients found in the seeds and their potential antimicrobial, anticancer, antiproliferative, antihypertensive, antidiabetic, antilipidemic, and cardioprotective characteristics as well as the use of seed oil in nutrition, fertilizer and biodiesel production, wastewater purification, cosmetics, and skin care products). 34151645
Azlan UK, Mediani A, Rohani ER, Tong X, Han R, Misnan NM, Jam FA, et al. A comprehensive review with updated future perspectives on the ethnomedicinal and pharmacological aspects of Moringa oleifera. Molecules. 2022;27:5765. (Review of the phytochemistry, biologic activities, and in vitro, in vivo, and human clinical studies of Moringa oleifera extracts). 36144493

## OTHER REFERENCE LINKS

Recent References on Moringa: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Moringa+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Moringa: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Moringa)